# Phenylbutyrate, Sodium Benzoate

## OVERVIEW

### Introduction

Phenylbutyrate and sodium benzoate are orphan drugs approved for the treatment of hyperammonemia in patients with urea cycle disorders, a series of at least 8 rare genetic enzyme deficiencies. The urea cycle is the major pathway of elimination of excess nitrogen including ammonia, and absence of one of the urea cycle enzymes often causes elevations in serum ammonia which can be severe, life-threatening and result in permanent neurologic damage and cognitive deficiencies. Both phenylbutyrate and sodium benzoate act by promoting an alternative pathway of nitrogen elimination. Neither phenylbutyrate nor sodium benzoate have been linked to cases of liver injury either in the form of serum enzyme elevations during therapy or clinically apparent acute liver injury.

### Phenylbutyrate

#### Background

Phenylbutyrate (fen" il beu' ti rate) is a prodrug that is metabolized to phenylacetate, which is the active molecule that combines with glutamine (an amino acid with two nitrogen molecules) to form phenylacetylglutamine, which is rapidly excreted by the kidneys and does not require metabolism via the urea cycle. Phenylbutyrate thus provides an “ammonia sink”, an alternative pathway for excretion of excess nitrogen and ammonia. The active metabolite phenylacetate is also effective therapeutically, but has a disagreeable odor and taste that affect compliance and acceptability. Phenylbutyrate is odorless but does have a bitter, salty taste and is better tolerated than phenylacetate, but still not well accepted, particularly because it must be given in high doses, often as 3 to 12 tablets three times daily. Nevertheless, phenylbutyrate has been found to be effective in lowering ammonia levels in newborns, children and adults with acute hyperammonemic crises as well as to maintain normal or near normal levels of ammonia in patients between episodes (sometimes brought on by infection or excess dietary protein). Sodium phenylbutyrate received orphan drug approval for this indication in 1996. It is available in tablets of 500 mg and as a powder for oral solution under the brand name Buphenyl. The typical dose varies by body weight or surface area, but is in general in the range of 5 to 20 grams daily given in three equally divided doses with meals. Phenylbutyrate is administered in conjunction with a low protein diet, often combined with sodium benzoate (another ammonia “sink”) and essential amino acids (such as citrulline or arginine). However, the regimen used must be individualized based upon the type of urea cycle disorder and specific clinical features. Phenylbutyrate should be administered only by physicians with expertise in managing urea cycle disorders and with proper diagnostic evaluation and monitoring. Common effects of sodium phenylbutyrate are bitter taste, loss of appetite, nausea, vomiting, diarrhea and edema. Rare side effects include fever and rash. Because of the need to calculate dosages, overdosing can easily occur. Accidental use of higher than appropriate doses of phenylbutyrate can result in severe metabolic side effects and death.

The poor acceptance of standard, sodium phenylbutyrate because of its bitter taste, high sodium content and pill burden (as many as 40 tablets daily) was a major impetus to the development of the glycerol-tri-phenylbutyrate, a formulation that is both tasteless and odorless, has a low sodium content and can be given orally as a liquid in a small volume. Glycerol phenylbutyrate was approved for treatment of hyperammonemia due to urea cycle disorders in 2013 and is available as an oral solution (1.1 g/mL) under the brand name Ravicti. The typical dose is 5 to 12 g/m^2^ daily (~5-10 mL) in three divided doses with meals. The common side effects of sodium phenylbutyrate such as bitter taste, anorexia, nausea and vomiting are less with glycerol phenylbutyrate and the high sodium intake of the standard formulation can be avoided. Nevertheless, care in calculation of the dose is critical, and monitoring of ammonia and drug levels during treatment is recommended.

#### Hepatotoxicity

While the urea cycle disorders are caused by deficiencies of hepatic enzymes responsible for the elimination of nitrogen, patients generally present with hyperammonemia without other features or biochemical evidence of hepatic injury. Thus, serum aminotransferase, alkaline phosphatase and bilirubin levels are generally normal or only mildly elevated. Newborns presenting with hyperammonemia may have hepatomegaly but other, non-urea cycle, liver function is normal as is hepatic histology. Phenylbutyrate can help to lower ammonia levels acutely and manage to keep them in the normal or near normal range, but generally does not affect other liver functions. In open label studies, a small proportion of patients (particularly with ornithine transcarbamylase [OTC] deficiency) have had ALT or AST elevations, but these have generally been attributed to the underlying condition or its complications. Phenylbutyrate has not been linked to instances of clinically apparent liver injury with jaundice.

Likelihood score: E (unlikely cause of clinically apparent liver injury, but experience with its use is limited).

### Sodium Benzoate

#### Introduction

Sodium benzoate was the first agent developed specifically for the therapy of hyperammonemia caused by urea cycle disorders. Like phenylbutyrate, sodium benzoate acts as an ammonia sink, eliminating nitrogen by an alternative pathways independent of the urea cycle. Sodium benzoate has not been linked to significant serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

#### Background

Sodium benzoate (ben' zoe ate) is a small molecule that conjugates with glycine (an amino acid with one nitrogen molecule) to form hippuric acid, which is rapidly excreted by the kidneys and does not require metabolism via the urea cycle. Sodium benzoate is an orphan drug that is approved for the treatment of hyperammonemia in patients with urea cycle disorders, a series of at least 8 rare genetic deficiencies of enzymes involved in the urea cycle and elimination of nitrogen waste. Sodium benzoate has been shown to result in a rapid decrease in serum ammonia levels in children and adults with urea cycle disorders. It is less effective than phenylbutyrate, perhaps because it conjugates to glycine which has a single nitrogen molecule as opposed to phenylbutyrate which conjugates to glutamate which possesses two nitrogens. Nevertheless, because sodium benzoate acts via a different amino acid than phenylbutyrate, the two drugs can be used in combination to treat refractory cases of hyperammonemia due to urea cycle disorders. Indeed, the combination of sodium benzoate with phenylbutyrate was approved for use in the United States in 1996 for the treatment of hyperammonemic crises in children and adults with urea cycle disorders. The combination of sodium benzoate and phenylacetate is available as a solution for injection in single dose vials (50 mL: 50 mg of each) generically and under the brand name Ammonul. Oral formulations of sodium benzoate are available in other countries of the world. The intravenous preparation is used only to treat hyperammonemic crises with encephalopathy and the dose varies by type of urea cycle disorder and body weight. The intravenous combination of sodium benzoate and phenyl-acetate or -butyrate should be administered only by a physician with expertise in the management of urea cycle disorders. The intravenous infusion should be given via a central and not peripheral line. Common effects of sodium benzoate are nausea, vomiting, injection site reactions, fever, and rash. Because this product is given to patients with severe hyperammonemia who are often critically ill, many of the reported adverse events are more likely due to the underlying conditions rather than the sodium benzoate and phenylbutyrate; they include cardiac arrhythmias, hypoglycemia, respiratory distress and failure, seizures, coma, clonus, liver failure and hyperammonemia.

#### Hepatotoxicity

While the urea cycle disorders are caused by deficiencies of hepatic enzymes responsible for the elimination of nitrogen, patients generally present with hyperammonemia without other features of hepatic injury. Thus, serum aminotransferase, alkaline phosphatase and bilirubin levels are generally normal or only mildly elevated. Newborns presenting with hyperammonemia may have hepatomegaly but other, non-urea cycle, liver function is normal as is hepatic histology. Sodium benzoate can help to lower ammonia levels acutely and manage to keep them in the normal or near normal range, but generally does not affect other liver functions. Transient and mild serum enzyme elevations have been described during therapy with sodium benzoate (with or without phenylbutyrate), but these are generally attributed to the underlying condition or its complications. Sodium benzoate has not been linked to instances of clinically apparent liver injury with jaundice.

Likelihood score: E (unlikely cause of clinically apparent liver injury, but experience with its use is limited).

Drug Class: Genetic Disorder Agents, Urea Cycle Disorder Agents (Hyperammonemia)

Other drugs in the Subclass: Carglumic Acid, Lactulose, Rifaximin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Glycerol Phenylbutyrate – Ravicti®

Sodium Phenylbutyrate – Generic, Buphenyl®

Sodium Benzoate and Sodium Phenylacetate – Generic, Ammonul®

DRUG CLASS

Urea Cycle Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Phenylbutyrate,%20Sodium%20Benzoate)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Phenylbutyrate | 1716-12-7 | C10-H11-Na-O2
Benzoate | 65-85-0 | C7-H6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 10 October 2016

Abbreviations used for urea cycle enzyme deficiencies: ASL, argininosuccinate lyase (citrullinemia); ASS, argininosuccinate synthetase; CPS, carbamylphosphate synthase; OTC, ornithine transcarbamylase.

Brusilow SW, Valle DL, Batshaw M. New pathways of nitrogen excretion in inborn errors of urea synthesis. Lancet 1979; 2 (8140): 452-4. (Initial description of biochemical basis for use of arginine, citrulline and sodium benzoate for hyperammonemia caused by urea cycle disorders, which take advantage of alternative pathways of excretion of excess nitrogen including ammonia). 89510
Batshaw ML, Brusilow S, Waber L, Blom W, Brubakk AM, Burton BK, Cann HM, et al. Treatment of inborn errors of urea synthesis: activation of alternative pathways of waste nitrogen synthesis and excretion. N Engl J Med 1982; 306: 1387-92. (Among 26 infants with 4 different urea cycle disorders and severe hyperammonemia treated with activators of alternative pathways of nitrogen excretion including sodium benzoate, citrulline and arginine for 7 to 62 months, 22 survived and most had normal or near normal plasma ammonia levels and “no serious side effects [of sodium benzoate] have been observed”, and serum ALT levels which were monitored during therapy “were normal or near normal”). 7078580
Brusilow SW, Danney M, Waber LJ, Batshaw M, Burton B, Levitsky L, Roth K, McKeethren C, Ward J. Treatment of episodic hyperammonemia in children with inborn errors of urea synthesis. N Engl J Med 1984; 310: 1630-4. (In 12 episodes of acute hyperammonemia occurring in 7 children with urea cycle disorders treated with a regimen of intravenous sodium benzoate, phenylacetate and arginine with nitrogen-free alimentation, 11 survived and “the only side effect of therapy was…nausea and vomiting with the priming infusion”). 6427608
Finkelstein JE, Hauser ER, Leonard CO, Brusilow SW. Late-onset ornithine transcarbamylase deficiency in male patients. J Pediatr 1990; 117: 897-902. (Among 21 males with OTC deficiency presenting after 28 days of age, all appeared normal at birth and developed episodic irritability, vomiting and lethargy, and 12 survived and were maintained on sodium benzoate, phenylacetate or phenylbutyrate, overall acceptance with strict compliance being poor [~17%]). 2246687
Dover GJ, Brusilow S, Charache S. Induction of fetal hemoglobin production in subjects with sickle cell anemia by oral sodium phenylbutyrate. Blood 1994; 84: 339-43. (Among 6 patients with sickle cell disease [ages 13 to 46 years] who were treated with phenylbutyrate [13 g/m2 daily] for 8-43 days, all had an increase in fetal hemoglobin, but compliance was poor and adverse events included rash, sodium overload, edema and fever; no mention of ALT elevations or hepatotoxicity). 7517215
Sodium phenylbutyrate for urea cycle enzyme deficiencies. Med Lett Drugs Ther 1996; 38 (988): 105-6. (Concise review of the mechanism of action, efficacy, side effects and costs of phenylbutyrate shortly after its approval for use in the urea cycle disorders in 1996; mentions that serum enzyme elevations have occurred during therapy, but are most likely due to the underlying disease). 8941257
Maestri NE, Brusilow SW, Clissold DB, Bassett SS. Long-term treatment of girls with ornithine transcarbamylase deficiency. N Engl J Med 1996; 335: 855-9. (Among 39 girls with OTC deficiency and episodic hyperammonemia who were treated with phenylbutyrate and/or sodium benzoate, frequency of hyperammonemic crises and survival appeared to be better than that of historic controls; adverse events including ALT elevations were not mentioned). 8778603
Feillet F, Leonard JV. Alternative pathway therapy for urea cycle disorders. J Inherit Metab Dis 1998; 21 Suppl 1: 101-11. (Review of the biochemistry of urea cycle disorders and rationale of use of agents that provide an alternative pathway for removal of nitrogen including sodium benzoate [glycine], phenylacetate and phenylbutyrate [glutamate] mentions that side effects in retrospective studies were difficult to attribute to therapy as opposed to the underlying disease). 9686348
Saudubray JM, Touati G, Delonlay P, Jouvet P, Narcy C, Laurent J, Rabier D, et al. Liver transplantation in urea cycle disorders. Eur J Pediatr 1999; 158 Suppl 2: S55-9. (Retrospective analysis of 175 French subjects with urea cycle disorders, mainly OTC [119: 68%], CPS [13: 6%], ASS [citrullinemia 28: 37%] and ASL deficiency [15: 8%], comments upon the frequency of death or poor outcome and possible role of early liver transplantation to avert the serious neurologic and cognitive sequelae). 10603100
Praphanphoj V, Boyadjiev SA, Waber LJ, Brusilow SW, Geraghty MT. Three cases of intravenous sodium benzoate and sodium phenylacetate toxicity occurring in the treatment of acute hyperammonaemia. J Inherit Metab Dis 2000; 23: 129-36. (Among 3 children [3-6 years old] with hyperammonemia due to urea cycle disorders who received inappropriate high doses of intravenous sodium benzoate and phenylacetate, all developed worsening somnolence, tachypnea and metabolic acidosis; two died and one survived after hemodialysis and with residual severe cognitive impairment). 10801054
Bogdanovic MD, Kidd D, Briddon A, Duncan JS, Land JM. Late onset heterozygous ornithine transcarbamylase deficiency mimicking complex partial status epilepticus. J Neurol Neurosurg Psychiatry 2000; 69: 813-5. (A 57 year old woman developed hyperammonemic coma after receiving valproate for refractory seizures and was found to have OTC deficiency, responding to dietary protein restriction and chronic phenylbutyrate therapy). 11080238
Redonnet-Vernhet I, Rouanet F, Pedespan JM, Hocke C, Parrot F. A successful pregnancy in a heterozygote for OTC deficiency treated with sodium phenylbutyrate. Neurology 2000; 54: 1008. (A 27 year old woman with OTC deficiency on long term therapy with phenylbutyrate and low protein diet delivered a normal infant at 33 weeks despite continuing low doses of phenylbutyrate during pregnancy).
Berry GT, Steiner RD. Long-term management of patients with urea cycle disorders. J Pediatr 2001; 138 (1 Suppl): S56-60. (Brief summary of phenylbutyrate therapy and management of patients with urea cycle disorders stressing the need for careful monitoring and individualized therapy). 11148550
Burlina AB, Ogier H, Korall H, Trefz FK. Long-term treatment with sodium phenylbutyrate in ornithine transcarbamylase-deficient patients. Mol Genet Metab 2001; 72: 351-5. (Among 9 children with OTC deficiency [4 boys, 5 girls] treated with phenylbutyrate for 17-42 months, ammonia levels were well controlled, there were no hyperammonemic episodes requiring hospitalization, and “no side effects related to therapy were observed”). 11286510
Batshaw ML, MacArthur RB, Tuchman M. Alternative pathway therapy for urea cycle disorders: twenty years later. J Pediatr 2001; 138 (1 Suppl): S46-54; discussion S54-5. (Review of the history of development of alternative pathway therapy for urea cycle disorders including sodium benzoate and phenylbutyrate). 11148549
Anadiotis G, Ierardi-Curto L, Kaplan PB, Berry GT. Ornithine transcarbamylase deficiency and pancreatitis. J Pediatr 2001; 138: 123-4. (A 15 year old boy with OTC deficiency, due to a rare mutation, developed pancreatitis while on phenylbutyrate and low protein diet given by gastrostomy tube [amylase 409 U/L, lipase 1172 U/L, ammonia 276 µmoL/L], followed by chronic amylase and lipase elevations, the cause being unclear; no information on whether phenylbutyrate was stopped). 11148526
Leonard JV, Morris AA. Urea cycle disorders. Semin Neonatol 2002; 7: 27-35. (Review of the biochemical and genetic basis for the urea cycle disorders, their management and therapy including low protein diet, arginine, citrulline, sodium benzoate, phenylbutyrate, carnitine and dialysis). 12069536
Gordon N. Ornithine transcarbamylase deficiency: a urea cycle defect. Eur J Paediatr Neurol 2003; 7: 115-21. (Review of OTC deficiency including use of sodium benzoate and phenylbutyrate; no discussion of side effects). 12788037
Tuchman M, Lee B, Lichter-Konecki U, Summar ML, Yudkoff M, Cederbaum SD, Kerr DS, Diaz GA, et al.; Urea Cycle Disorders Consortium of the Rare Diseases Clinical Research Network. Cross-sectional multicenter study of patients with urea cycle disorders in the United States. Mol Genet Metab 2008; 94: 397-402. (Among 183 patients with urea cycle disorders enrolled in a US consortium, causes included OTC deficiency [55%], ASA deficiency [16%] and citrullinemia [14%]; 63% were on a protein restricted diet, 37% phenylbutyrate and 5% sodium benzoate; no discussion of side effects). 18562231
Summar ML, Dobbelaere D, Brusilow S, Lee B. Diagnosis, symptoms, frequency and mortality of 260 patients with urea cycle disorders from a 21-year, multicenter study of acute hyperammonaemic episodes. Acta Paediatr 2008; 97: 1420-5. (Among 260 patients with urea cycle disorders presenting at four referral centers between 1982 and 2003, deficiencies included OTC [55%], ASS [27%], CPS [14%] and ASL [3%]; 985 hospitalizations for a hyperammonemic episode occurred, often following an acute, intercurrent illness [58%] or noncompliance [15%] and survival varied greatly by diagnosis and age of presentation). 18647279
Walker V. Ammonia toxicity and its prevention in inherited defects of the urea cycle. Diabetes Obes Metab 2009 Sep; 11: 823-35. (Review of hyperammonemia and its treatment in urea cycle disorders including use of sodium benzoate and phenylbutyrate; mentions side effects of mucositis, but not ALT elevations or hepatotoxicity). 19531057
McGuire BM, Zupanets IA, Lowe ME, Xiao X, Syplyviy VA, Monteleone J, Gargosky S, et al. Pharmacology and safety of glycerol phenylbutyrate in healthy adults and adults with cirrhosis. Hepatology 2010; 51: 2077-85. (Single dose, single-day and multiple-day dosing with glycerol phenylbutyrate in healthy adults and patients with cirrhosis found that the glycerol formulation achieved similar drug levels, had similar metabolism [with and without cirrhosis] and was not associated with serious adverse events or significant changes in liver test abnormalities). 20512995
Lee B, Rhead W, Diaz GA, Scharschmidt BF, Mian A, Shchelochkov O, Marier JF, et al. Phase 2 comparison of a novel ammonia scavenging agent with sodium phenylbutyrate in patients with urea cycle disorders: safety, pharmacokinetics and ammonia control. Mol Genet Metab 2010; 100: 221-8. (Among 10 adults with urea cycle disorders and episodic hyperammonemia who were switched from sodium phenylbutyrate to glycerol tri-phenylbutyrate, ammonia levels were better maintained and no hyperammonemic episodes occurred on the glycerol formulation which was better tolerated and accepted by patients). 20382058
Cederbaum S, Lemons C, Batshaw ML. Alternative pathway or diversion therapy for urea cycle disorders now and in the future. Mol Genet Metab 2010; 100: 219-20. (Commentary on the publication by Lee [2010] reviewing the history of development of alternative pathway therapy of the urea cycle disorders, the difficulty of getting these agents approved and the promising new glycerol formulation of phenylbutyrate that promises to solve the problems of poor acceptance, high pill count and excess sodium intake associated with the standard formulation). 20462778
Nagamani SC, Erez A, Lee B. Argininosuccinate lyase deficiency. Genet Med 2012; 14: 501-7. (Review of argininosuccinate lyase [ASL] deficiency, the second most frequent urea cycle disorder, its biochemical and genetic basis, clinical features, management, therapy and prognosis, therapy focusing upon low protein diet, sodium benzoate, phenylbutyrate and arginine replacement). 22241104
Iannitti T, Palmieri B. Clinical and experimental applications of sodium phenylbutyrate. Drugs R D. 2011; 11: 227-49. (Discussion of the other possible, although still unproven, mechanisms of action and uses of phenylbutyrate including as a histone deacetylase inhibitor and drug chaperone [in cancer chemotherapy, sickle cell disease, cystic fibrosis and Huntington disease]). 21902286
Lichter-Konecki U, Diaz GA, Merritt JL 2nd, Feigenbaum A, Jomphe C, Marier JF, Beliveau M, et al. Ammonia control in children with urea cycle disorders (UCDs); phase 2 comparison of sodium phenylbutyrate and glycerol phenylbutyrate. Mol Genet Metab 2011; 103: 323-9. (Among 11 patients with urea cycle disorders who were switched from sodium phenylbutyrate to glycerol-tri-phenylbutyrate, ammonia levels were lower with the new formulation which was also better accepted; no safety issues or coma episodes arose during therapy with the new formulation). 21612962
Guffon N, Kibleur Y, Copalu W, Tissen C, Breitkreutz J. Developing a new formulation of sodium phenylbutyrate. Arch Dis Child 2012; 97: 1081-5. (Comparison of taste profile, tolerance and pharmacokinetics of standard vs glycerol phenylbutyrate in 13 healthy volunteers, found similar maximal plasma levels and bioequivalence, but no bitter taste and better acceptability of the glycerol formulation). 22941860
Guha M. Urea cycle disorder drug approved. Nat Biotechnol 2013; 31: 274. (News article announcing the FDA approval of glycerol phenylbutyrate for urea cycle disorders which is likely to replace standard sodium phenylbutyrate because of its heavy pill count, high sodium content and bitter taste). 23563410
Smith W, Diaz GA, Lichter-Konecki U, Berry SA, Harding CO, McCandless SE, LeMons C, et al. Ammonia control in children ages 2 months through 5 years with urea cycle disorders: comparison of sodium phenylbutyrate and glycerol phenylbutyrate. J Pediatr 2013; 162: 1228-34. (Among 15 children with urea cycle disorders who were switched from standard to glycerol-phenylbutyrate in an open label study, the glycerol formulation was non-inferior in controlling of ammonia levels and had better acceptability; there were no serious adverse events or changes in serum chemistry measures during dosing). 23324524
Lamb S, Aye CY, Murphy E, Mackillop L. Multidisciplinary management of ornithine transcarbamylase (OTC) deficiency in pregnancy: essential to prevent hyperammonemic complications. BMJ Case Rep 2013; 2013. (A 29 year old woman with OTC deficiency was managed during a successful pregnancy with a resultant normal neonate, but the details or diet, sodium benzoate, phenylbutyrate and arginine doses were not provided).
Diaz GA, Krivitzky LS, Mokhtarani M, Rhead W, Bartley J, Feigenbaum A, Longo N, et al. Ammonia control and neurocognitive outcome among urea cycle disorder patients treated with glycerol phenylbutyrate. Hepatology 2013; 57: 2171-9. (Analyses of a pivotal trial, short term studies of ammonia control and of long term open label studies using glycerol tri-phenylbutyrate reported similar control of ammonia levels compared to standard phenylbutyrate, but better acceptability; there were “no clinically significant laboratory” changes but common adverse events included nausea and vomiting, diarrhea, headache and decreased appetite, but no instances of clinically apparent liver injury besides hyperammonemia). 22961727
Mistry PK. Rare disease clinical research network's urea cycle consortium delivers a successful clinical trial to improve alternate pathway therapy. Hepatology 2013; 57: 2100-2. (Editorial accompanying article by Diaz [2013] summarizing the history of development of alternate pathway therapy for the urea cycle disorders and the important role of a better accepted formulation of phenylbutyrate). 23080135
Kibleur Y, Dobbelaere D, Barth M, Brassier A, Guffon N. Results from a Nationwide Cohort Temporary Utilization Authorization (ATU) survey of patients in France treated with Pheburane(®) (Sodium Phenylbutyrate) taste-masked granules. Paediatr Drugs 2014; 16: 407-15. (Among 25 patients with urea cycle disorders in France treated with taste-masked granules of phenylbutyrate [mean dose 5.2 g or 211 mg/kg daily] on a compassionate use basis for 1-11 months while the agent was being evaluated for approval, none had a hyperammonemic episode and “no patient reported any adverse event”). 24962711
Berry SA, Lichter-Konecki U, Diaz GA, McCandless SE, Rhead W, Smith W, Lemons C, et al. Glycerol phenylbutyrate treatment in children with urea cycle disorders: pooled analysis of short and long-term ammonia control and outcomes. Mol Genet Metab 2014; 112: 17-24. (Pooled analysis of 2 studies of glycerol vs sodium phenylbutyrate showed that ammonia levels were better controlled with the glycerol formulation which also had better acceptability). 24630270
Batshaw ML, Tuchman M, Summar M, Seminara J; Members of the Urea Cycle Disorders Consortium. A longitudinal study of urea cycle disorders. Mol Genet Metab 2014; 113 (1-2): 127-30. (Overview of the Urea Cycle Disorders Consortium and its ongoing clinical studies including a longitudinal analysis showing that phenylbutyrate therapy was associated with lower plasma levels of branched chained amino acids and another analysis showing that liver dysfunction was not uncommon in patients with OTC deficiency). 25135652
Glycerol phenylbutyrate (Ravicti) for urea cycle disorders. Med Lett Drugs Ther 2014; 56 (1449): 77-8. (Concise review of the mechanism of action, clinical efficacy, safety and costs of glycerol phenylbutyrate as therapy of hyperammonemia in the urea cycle disorders, mentions that common adverse effects include diarrhea, flatulence and headache; no mention of ALT elevations or hepatotoxicity). 25118801
Martín-Hernández E, Aldámiz-Echevarría L, Castejón-Ponce E, Pedrón-Giner C, Couce ML, Serrano-Nieto J, Pintos-Morell G, et al. Urea cycle disorders in Spain: an observational, cross-sectional and multicentric study of 104 cases. Orphanet J Rare Dis 2014; 9: 187. (Cross-sectional analysis of 104 patients with urea cycle disorders from 98 families and 21 centers in Spain found most common form was ornithine transcarbamylase deficiency [64%], followed by type 1 citrullinemia [21%] and argininosuccinic aciduria [10%]; most were treated with essential amino acid replacement, some with sodium benzoate, phenylbutyrate and one with carglumic acid [with NAGS deficiency]). 25433810
Matoori S, Leroux JC. Recent advances in the treatment of hyperammonemia. Adv Drug Deliv Rev 2015; 90: 55-68. (Review of the causes and treatments of hyperammonemia focusing upon newer agents such as rifaximin, sodium benzoate, carglumic acid and phenylbutyrate). 25895618
Lee B, Diaz GA, Rhead W, Lichter-Konecki U, Feigenbaum A, Berry SA, Le Mons C, et al. Glutamine and hyperammonemic crises in patients with urea cycle disorders. Mol Genet Metab 2016; 117: 27-32. (In longitudinal studies among 100 patients with urea cycle disorders in clinical trials of glycerol phenylbutyrate, plasma arginine showed less variability than ammonia levels, but was less reliable in predicting episodes of severe hyperammonemia). 26586473

## OTHER REFERENCE LINKS

Recent References on Phenylbutyrate, Sodium Benzoate: from PubMed.gov (https://pubmed.ncbi.nlm.nih.gov/?cmd=search&pubmedfilters=true&term=(Phenylbutyrate,+Sodium+Benzoate)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice%2FCI+OR+bile+duct+diseases%2FCI+OR+liver%2FDE+OR+liver+diseases%2FCI)+AND+(%221900%2F1%2F1%22%5BEDat%5D%3A%222999%2F12%2F31%22%5BEDat%5D))

Trials on Phenylbutyrate, Sodium Benzoate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Phenylbutyrate,%20Sodium%20Benzoate)